# Sildenafil

## OVERVIEW

### Introduction

Sildenafil functions as a selective and competitive inhibitor of type 5 phosphodiesterases (PDE5) on smooth muscle cells in the penis and pulmonary vasculature, and is used extensively for erectile dysfunction and less commonly for pulmonary hypertension. Sildenafil has been associated with rare instances of clinically apparent liver injury.

### Background

Sildenafil (sil den' a fil) is an inhibitor of type 5 phosphodiesterase (PDE5), the enzyme isoform that is found predominantly in the penis and lungs. Inhibition of PDE5 leads to prolongation of activation of cyclic guanosine monophosphate (cGMP), a major mediator of the vasodilatory action of nitric oxide (NO). Inhibition of PDE5 leads to prolongation of smooth muscle relaxation in the corpus cavernosum of the penis (improving erections) and in the pulmonary vasculature (decreasing pulmonary artery pressure). Sildenafil was approved for use in the therapy of erectile dysfunction in the United States in 1998 and is available generically and under the brand name Viagra in tablets of 25, 50 and 100 mg. Worldwide, more than 20 million men have used sildenafil for erectile dysfunction. The recommended dose is 50 mg as a single dose approximately one hour before sexual activity, with dose increase or decrease based upon tolerance and effectiveness with a recommended maximum frequency of once daily and maximum amount of 100 mg. Sildenafil is also approved for use in pulmonary hypertension as tablets of 20 mg generically and under the brand name Revatio. The recommended dosage for pulmonary hypertension is 20 mg three times daily. An intravenous formulation of sidenafil is also available in 10 mg vials for more emergent treatment of pulmonary artery hypertension, the recommended dosage being 10 mg intravenously three times daily. Common side effects include dizziness, headache, flushing, hypotension, rhinitis and dyspepsia. Rare, but potentially serious adverse events include vision and hearing loss, hypotension, cardiovascular events and priapism.

### Hepatotoxicity

There have been at least 5 reports of acute liver injury attibuted to sildenafil use, but no instances of acute hepatic failure. The latency in most reports has been unclear because of the intermittent and sometimes unacknowledged use of sildenafil, but appears to be within 1 to 8 weeks. The pattern of serum enzyme elevations has ranged from hepatocellular to cholestatic, sometimes evolving from one to the other. The most convincing cases have been a mild cholestatic or "mixed" hepatitis arising within 1 to 3 months of starting sildenafil. Immunoallergic features and autoantibodies were not observed. Cases of acute onset with high serum aminotransferase levels have been reported after use of sildenafil that have some characteristics of ischemic injury. In other instances, the pattern of injury suggested anabolic steroid use. In two cases, re-exposure did not result in recurrence. Thus, the hepatotoxicity of sildenafil is not completely convincing and must be quite rare, if it occurs at all.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatic injury due to sildenafil is still unknown, but it is metabolized by the P450 system (CYP 3A4), and idiosyncratic production of a toxic intermediate may underlie cases of hepatotoxicity from the agent. In some instances, ischemic injury to the liver may be responsible for acute, self-limited injury due to hypotension or an acute cardiac event triggered by sildenafil induced vasodilation or sexual activity, particularly if they are taken with nitrates.

### Outcome and Management

Cases of acute liver injury from sildenafil have been self-limited, and full recovery occurred in all reported cases without residual liver injury or vanishing bile duct syndrome. Rechallenge has not been reported to lead to recurrence, and cross reactivity with other PDE5 inhibitors has not been reported. Nevertheless, switching to another PDE5 inhibitor after clinically apparent liver injury should be done with caution.

References to sidenafil induced liver injury are provided in the Overview section on PDE5 Inhibitors.

Drug Class: PDE5 Inhibitors

Other Drugs in the Class: Avanafil, Tadalafil, Vardenafil

## CASE REPORT

### Case 1. Acute cholestatic hepatitis caused by sildenafil.

[Modified from: Wolfhagen FH, Vermeulen HG, de Man RA, Lesterhuis W. Initially obscure hepatotoxicity attributed to sildenafil. Eur J Gastroenterol Hepatol 2008; 20: 710-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18679077)]

A 59 year old man developed fatigue, nausea and jaundice that persisted for several weeks. When initially seen, blood tests showed serum bilirubin of 5.2 mg/dL with marked elevation in aminotransferase levels (ALT 1665 U/L, AST 1077 U/L), but minimal increases in alkaline phosphatase (173 U/L) (Table). Because of persistence of jaundice and pruritus, he was admitted for evaluation. Physical examination revealed jaundice and hepatic tenderness. Serum bilirubin rose to 19 mg/dL. Tests for hepatitis A, B and C and for CMV and EBV were negative as were autoantibodies. Ultrasound showed no evidence of biliary tract disease. A liver biopsy showed severe intrahepatic cholestasis and eosinophils in portal areas suggestive of drug induced liver injury. At this point, the patient admitted to taking sildenafil in doses of 50 mg several times per week for the 3 months before onset of illness. He took no other medications and drank alcohol sparingly. Over the ensuing 1 to 2 months, he recovered and all laboratory tests returned to normal.

#### Key Points

Medication: | Sildenafil (50 mg daily, several times weekly)
Pattern: | Hepatocellular evolving into cholestatic (R=~40 → 2)
Severity: | 3+ (jaundice and hospitalization)
Latency: | ~3 months
Recovery: | ~3 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Sildenafil used several times per week for 3 months before onset of symptoms
3 months | 0 | 1665 | 173 | 5.2 | Outpatient evaluation
| 1 week | 120 | 140 | 7.9
4 months | 4 weeks | 59 | 150 | 15.0 | Hospitalization
| 7 weeks | 70 | 210 | 17.8 | Severe pruritus
5 months | 8 weeks | 65 | 145 | 19.0 | Liver biopsy
| 9 weeks | 40 | 125 | 13.5
6 months | 10 weeks | 35 | 105 | 5.6
| 14 weeks | 30 | 90 | 1.5
7 months | 4 months | 20 | 75 | 0.7
8 months | 5 months | 25 | 75 | 0.7 | Asymptomatic
Normal Values | | <40 | <100 | <1.2

*Selected values estimated from Figure 1.

#### Comment

The clinical course was typical for a cholestatic drug induced liver injury and, in the absence of evidence for biliary disease and lack of other medication exposure, sildenafil is certainly suspect. This report is perhaps the most convincing example of drug induced liver injury from sildenafil. The clinical course was also compatible with liver injury from anabolic steroids, which are often not mentioned in a routine history. Rechallenge was not performed because of the severity and duration of the hepatic injury; an appropriate decision.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sildenafil – Generic, Viagra®, Revatio®

DRUG CLASS

PDE5 Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=sildenafil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Sildenafil | 139755-83-2 | C22-H30-N6-O4-S | Sildenafil chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Sildenafil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=sildenafil/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Sildenafil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sildenafil)